# Antifungal Agents

## OVERVIEW

Antifungal drugs are a diverse group of medications used to treat fungal infections ranging from ringworm and athletes foot to esophageal candidiasis, coccidiomycosis, and cryptococcal meningitis. The antifungals are classified into several groups based on their structure and mechanisms of action. These classes include the polyenes, imidazoles, triazoles, allylamines, and echinocandins, as well as miscellaneous agents.

Polyene antifungals have an amphiphilic structure which binds to ergosterol, converting the fluid cell membrane of the fungal cell into a more crystalline state increasing permeability and precipitating cell lysis. Examples of polyenes (with date of approval and common brand names) include nystatin (1971: Mycostatin, Nystat) and amphotericin B (1971: Amphocin, Fungizone).

Imidazole and triazole antifungal drugs inhibit cytochrome P450 14α-demethylase which is responsible for converting lanosterol to ergosterol, which blocks cell membrane synthesis in fungi. Examples of imidazoles include ketoconazole (1981: Nizoral) and clotrimazole (1975: Mycelex). Examples of triazoles include fluconazole (1990: Diflucan), itraconazole (1992: Sporanox), posaconazole (2006: Noxafil) and voriconazole (2002: Vfend). Isavuconazonium (Cresemba: 2016) is a prodrug of isavuconazole and is available in both intravenous and oral forms, its indications restricted for serious, invasive fungal infections such as aspergilosis and mucormycosis. The triazoles are perhaps the most commonly used antifungal agents having excellent oral absorption, tolerance and tissue penetration.

The allylamines inhibit the enzyme squalene epoxidase, which is also required for ergosterol and thus fungal cytoplasmic membrane synthesis. An example of an allylamine is terbinafine (1998: Lamisil).

Echinocandins are the newest class of fungicidal agents. They inhibit the synthesis of β-D-glucan in fungal cell walls via inhibition of the enzyme 1,3-β glucan synthase. Examples of echinocandins include anidulafungin (2006: Eraxis), caspofungin (2001: Cancidas) and micafungin (2005: Mycamine). The echinocandins are administered intravenously and used largely for serious invasive fungal infections.

The miscellaneous fungicidal agents include the antimetabolite flucytosine (1971: Ancobon) and the microtubule inhibitor griseofulvin (2007: Grifulvin). Because pneumocystitis jiroveci (formerly carinii) is now considered a fungal agent, pentamine (1984: Pentam) may be considered a miscellaneous antifungal agent.

In general, the treatment of fungal infections is based upon inhibition of cell processes that are necessary in fungi, but do not harm critical cell pathways in human cells. Both fungi and humans are eukaryotic organisms and they share many cellular enzymes and pathways. These features account for the range of side effects seen with many antifungal agents. Most antifungal agents have been implicated in causing some degree of hepatotoxicity; clinically apparent liver injury with jaundice occurs most prominently with ketoconazole, fluconazole, voriconazole, and terbinafine.

The following drug records are discussed individually:

• Amphotericin B

• Anidulafungin

• Caspofungin

• Clotrimazole

• Echinocandins

• Fluconazole

• Flucytosine

• Griseofulvin

• Ibrexafungerp

• Isavuconazonium

• Itraconazole

• Ketoconazole

• Micafungin

• Nystatin

• Pentamidine

• Posaconazole

• Terbinafine

• Voriconazole

## ANNOTATED BIBLIOGRAPHY

References updated: 18 May 2017

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 discusses amphotericin, flucytosine, pentamidine, griseofulvin, ketoconazole, itraconazole, clotrimazole, and terbinafine).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents discusses amphotericin, caspofungin, ketoconazole, fluconazole, itraconazole, voriconazole, posaconazole, terbinafine, flucytosine and griseofulvin ).
Bennett JE. Antifungal agents. In, Brunton LL, Chabner B, Knollman K, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 157191. (Textbook of pharmacology and therapeutics).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. 18955056 (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 8 cases [2.7%] were attributed to antifungal agents, including 4 due to terbinafine, 2 to fluconazole, 1 each to ketoconazole and itraconazole, none to voriconazole, amphotericin or the echinocandins).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. 20949552 (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 6 [4.5%] were caused by antifungal agents including 3 attributed to terbinafine, 2 ketoconazole, 1 itraconazole, but none to fluconazole, amphotericin B or the echinocardins).
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. 23750489 (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents; the incidence rates per 10,000 persons were 31.6 for fluconazole [12 cases, including the only 6 cases that were fatal], 4.9 for ketoconazole, 4.3 griseofulvin, 3.6 itraconazole and 1.6 terbinafine).
Antifungal drugs. Treat Guidel Med Lett 2012; 10 (120): 61-8. 22825657 (Concise summary of recommendations and guidelines for use of antifungal drugs including the imidazoles and triazoles, echinocandins, terbinafine, flucytosine, and amphotericin; liver adverse events are mentioned for terbinafine, ketoconazole, fluconazole, itraconazole, posaconazole and voriconazole).
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. 25232453 (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94], and posaconazole [70]; among 112 cases with acute liver failure causes included fluconazole [31], terbinafine [27], voriconazole [19], amphotericin B [14], ketoconazole [6], posaconazole [5], and itraconazole [4]; liver injury from echinocandins was less frequent and cases attributed to nystatin, and nystatin even less).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 7 due to terbinafine, 6 triazoles [4 fluconazole, 1 ketoconazole and 1 voriconazole], 1 micafungin and none amphotericin).
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. 26597673 (Among 195,334 persons treated with oral azole antifungal agents analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L ranged from 1.3 to 19% and severe acute liver injury from none to 9.3%, highest rates associated with posaconazole and vorconazole; one death was reported which was attributed to ketoconazole).
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-165. 27927037 (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity).